# Clonidine

## OVERVIEW

### Introduction

Clonidine is a centrally active alpha-adrenergic agonist used predominantly as an antihypertensive agent, usually in combination with other agents. Despite wide scale use for many years, clonidine has not been linked definitively to either serum aminotransferase elevations or clinically apparent liver injury.

### Background

Clonidine (klon' i deen) is an antihypertensive agent which acts by stimulation of the alpha 2A subtype of alpha adrenergic receptors in the brainstem, causing a reduction in the sympathic outflow of the central nervous system. Decreases in plasma levels of norepinephrine correlate closely with its antihypertensive effects. Clonidine is effective in lowering blood pressure and can be used alone or in combination with other antihypertensive medications. Clonidine is also used in several other conditions in which central nervous system sympathetic activity is believed to contribute including neuropathy, smoking and alcohol cessation, attention deficit disorder, vascular headache, menopausal symptoms, diabetic diarrhea, and restless leg syndrome. Clonidine was approved for use in the United States in 1974 and continues to be widely used with more than 11 million prescriptions being filled yearly. Current approved indications are for treatment of hypertension, but some preparations are also approved for cancer pain management and treatment of attention deficit disorder. Off label uses include treatment of Tourette syndrome, migraine headaches, stress and sleep disorders, and to alleviate symptoms of alcohol, nicotine or narcotic withdrawal. Clonidine is available in tablets of 0.1, 0.2 and 0.3 mg generically and under the brand name of Catapres. Clonidine is also available in fixed combination with diuretics, as a solution for injection and in a transdermal formulation for application once weekly. The typical maintenance dose of clonidine in adults is 0.1 to 0.6 mg daily in 2 to 3 divided doses. Side effects are usually mild and include sedation, fatigue, bradycardia, dry mouth, headaches, dizziness, postural hypotension, male impotence and gastrointestinal upset. Sudden withdrawal can cause rebound hypertension.

### Hepatotoxicity

Serum aminotransferase elevations during clonidine therapy are uncommon and rates of such elevations have not been reported in the large clinical trials, demonstrating its efficacy in hypertension. Despite many decades of use, clonidine has not been implicated in instances of clinically apparent acute liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Clonidine is metabolized by the cytochrome P450 (CYP) system to a major degree but is typically administered in very low doses (less than 1 mg daily) and neither induces or inhibits CYP activity, which may account in part for its relative lack of hepatotoxicity.

Drug Class: Antihypertensive Agents, ADHD Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Clonidine – Generic, Catapres®

DRUG CLASS

Antihypertensive Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=clonidine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Clonidine | 4205-90-7 | C9-H9-Cl2-N3

## ANNOTATED BIBLIOGRAPHY

References updated: 25 August 2021

Zimmerman HJ. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 639-71. (Expert review of hepatotoxicity published in 1999; clonidine is not discussed).
Bhardwaj SS, Chalasani NP. Antihypertensive agents: Hepatotoxicity of cardiovascular and antidiabetic medications. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 603. (Review of hepatotoxicity of hypertensive agents published in 2007; “clonidine does not seem to cause hepatotoxicity”).
Michel T, Hoffman BB. Therapy of myocardial ischemia and hypertension. In, Brunton LL, Lazo JS, Parker KL, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 745-88. (Textbook of pharmacology and therapeutics; clonidine, guanabenz, and guanfacine stimulate the alpha 2A subtype of the alpha adrenergic receptors in the brainstem and result in reduction in sympathetic outflow from the CNS).
Ferder L, Inserra F, Medina F. (1987). Safety aspects of long-term antihypertensive therapy (10 years) with clonidine. J Cardiovasc Pharmacol. (Among 128 patients with hypertension treated with clonidine for up to 10 years, common side effects were drowsiness, dry mouth, constipation, dizziness, postural hypotension and male impotence; there were no significant changes in ALT, AST or Alk P and no discontinuations for liver test abnormalities).
Berg PA. (1993). Dtsch Med Wochenschr. (83 year old woman on long term clonidine for hypertension and recent addition of enalapril and HCTZ developed fatigue, dry mouth and elevated Alk P and ANA positivity [few details given], which was interpreted as possibly due to clonidine).
Heilmann G, Hien P. (1994). Dtsch Med Wochenschr. (Discussion of the likelihood that ACE inhibitors rather than clonidine were the cause of a lupus-like syndrome with hepatotoxicity discussed by Berg [1993]).
(2009). Drugs for hypertension. Treat Guidel Med Lett. (Brief overview of currently available drugs for hypertension with guidelines on their use and information on prices and toxicities; “Drugs such as clonidine, guanabenz, guanfacine and methyldopa decrease sympathetic outflow… and frequently cause sedation, dry mouth and erectile dysfunction”).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 39 cases [4%] were due to antihypertensive medications, but none to clonidine).
(2017). Drugs for hypertension. Med Lett Drugs Ther. (Brief overview of currently available drugs for hypertension with guidelines on their use and information on prices and toxicities; clonidine is listed as a central alpha-adrenergic agonist whose most frequent side effects are dry mouth, sedation, heart block, bradycardia and rebound hypertension; no mention of ALT elevations or hepatotoxicity).
Padilha SCOS, Virtuoso S, Tonin FS, Borba HHL, Pontarolo R. (2018). Efficacy and safety of drugs for attention deficit hyperactivity disorder in children and adolescents: a network meta-analysis. Eur Child Adolesc Psychiatry. (Systematic review of efficacy and safety of drugs for ADHD based upon 48 trials [4169 participants]; makes no mention of ALT elevations or hepatotoxicity of any of the agents studied, including guanfacine).
Cortese S, Adamo N, Mohr-Jensen C, Hayes AJ, Bhatti S, Carucci S, Del Giovane C, et al., European ADHD Guidelines Group (EAGG). (2017). Comparative efficacy and tolerability of pharmacological interventions for attention-deficit/hyperactivity disorder in children, adolescents and adults: protocol for a systematic review and network meta-analysis. BMJ Open. (Review of the pharmacological therapy of ADHD with discussion of amphetamines, methylphenidate, atomoxetine, guanfacine and clonidine; no mention of ALT elevations during therapy or hepatotoxicity).
Schoretsanitis G, de Leon J, Eap CB, Kane JM, Paulzen M. (2019). Clinically significant drug-drug interactions with agents for attention-deficit/hyperactivity disorder. CNS Drugs. (Review of drug-drug interactions of agents used to treat ADHD mentions that there is little information on the metabolism of clonidine and possible drug-drug interactions).
Drugs for ADHD. (2020). Med Lett Drugs Ther. (Concise review of mechanism of action, clinical efficacy, safety and cots of drugs for ADHD mentions that clonidine is a nonstimulatory agent that is generally well tolerated; no mention of ALT elevations or hepatotoxicity).
(2020). Drugs for hypertension. Med Lett Drugs Ther. (Brief overview of currently available drugs for hypertension with guidelines on their use and information on prices and toxicities; clonidine is listed as a central alpha-adrenergic agonist used mostly as add-on treatment in patients with refractory hypertension, which can cause sedation, dry mouth, and erectile dysfunction; no mention of ALT elevations or hepatotoxicity).
Burek GA, Waite MR, Heslin K, Liewen AK, Yaqub TM, Larsen SE. (2021). Low-dose clonidine in veterans with Posttraumatic stress disorder. J Psychiatr Res. (Retrospective analysis of 79 male, military veterans with severe post-traumatic stress disorder [PTSD] who were treated with low doses of clonidine [0.05 to 0.5 mg daily] in whom mean Clinical Global Impression scores improved from 4.8 to 2.9, and 23% of whom reported adverse events which were mostly mild, with no serious adverse events and no mention of hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Clonidine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Clonidine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Clonidine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Clonidine)